# Ozanimod

## OVERVIEW

### Introduction

Ozanimod is an orally available, sphingosine-1-phosphate (S1P) receptor modulator that acts as an immunomodulatory drug and is used to treat relapsing forms of multiple sclerosis and moderate-to-severe ulcerative colitis. Ozanimod is associated with transient serum enzyme elevations during therapy but has not been linked to instances of clinically apparent liver injury with jaundice, although experience with its use has been limited.

### Background

Ozanimod (oh zan’ i mod) is an orally available, sphingosine-1-phosphate (S1P) receptor modulator that is used to treat relapsing forms of multiple sclerosis and moderate-to-severe ulcerative colitis. Ozanimod is an analogue of sphingosine and is related in structure to fingolimod, the first S1P receptor inhibitor approved for use in multiple sclerosis. While fingolimod has nonspecific S1P receptor activity affecting receptor subtypes 1, 3, 4 and 5, siponimod, the second such analogue approved and ozanimod, the third, have a more limited specificity and primarily block S1P receptor 1 and 5 activity. The S1P receptor modulators, once phosphorylated intracellularly, render T and B cells insensitive to signals necessary for egress from lymphoid tissue. In animal models of multiple sclerosis, ozanimod resulted in reduced recirculation of autoaggressive lymphocytes to the central nervous system. Subsequently, in several large, randomized controlled trials, ozanimod was shown to reduce relapse rates and improve neuro-radiologic outcomes in adult patients with relapsing multiple sclerosis. Ozanimod was approved for use in the United States in 2020 as therapy of relapsing multiple sclerosis, and in 2021 its indications were broadened to include moderate-to-severe ulcerative colitis in adults. Ozanimod is available in tablets of 0.23, 0.46 and 0.92 mg under the brand name Zeposia. As with other S1P receptor modulators, a short period of dose escalation is recommended for initiation of therapy with ozanimod. The recommended maintenance dose in adults is 0.92 mg orally once daily. Ozanimod has also been shown to have beneficial effects in Crohn disease, but has yet to be approved for this indication. Common side effects of ozanimod, as with other S1P receptor modulators, are lymphopenia, headache, diarrhea, cough, rhinorrhea and back and abdominal pain. Rare, but potentially severe adverse events include severe viral, bacterial or fungal infections, atrial arrhythmias and bradycardia, macular edema, decrease in pulmonary function, progressive multifocal leukoencephalopathy (PML), and embryonal-fetal toxicity. Patients on long term ozanimod therapy should be monitored for infectious complications as well as for cardiac, pulmonary and ophthalmologic status.

### Hepatotoxicity

In large controlled trials of ozanimod in patients with multiple sclerosis, serum ALT elevations were common (~5% of recipients) but were typically mild and asymptomatic, and they returned to baseline values within a few months of stopping and often even with continuation of therapy. Aminotransferase elevations above 3 times upper limit of normal (ULN) were reported in 5% of ozanimod recipients compared to less than 1% of placebo recipients and elevations above 5 times ULN in 1%. In these prelicensure clinical trials, there were no cases of acute hepatitis or clinically apparent liver injury but elevations in liver tests led to discontinuation in approximately 1% of subjects. While ozanimod is associated with lymphopenia and long term therapy is associated with risk for reactivation of herpes simplex and zoster infections, it has not been linked to cases of reactivation of hepatitis B although one such instance has been reported with fingolimod. Thus, mild-to-moderate and transient serum enzyme elevations during therapy are not uncommon, but clinically apparent liver injury with jaundice due to ozanimod has not been reported, although the clinical experience with its use has been limited.

Likelihood score: E* (suspected but unproven cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which ozanimod might cause liver injury is not known. It is extensively metabolized by liver via the cytochrome P450 system, predominantly CYP 2C9 and 3A4 and drug-drug interactions with agents that induce or inhibit these enzymes are likely to occur. Serum enzyme elevations have been frequent with all of the oral S1P receptor modulators, particularly with fingolimod.

### Outcome and Management

While chronic therapy with ozanimod can be associated with mild-to-moderate serum aminotransferase elevations, it has not been linked to any cases of clinically apparent liver injury. Because of the frequency of enzyme elevations detected during therapy, the product label for ozanimod recommends obtaining baseline liver tests before initiation of treatment. However, no specific recommendations for monitoring liver tests during treatment have been made. Any ALT or AST elevation associated with symptoms or jaundice should lead to prompt discontinuation of ozanimod. Patients with persistent elevations above 3 times ULN should be assessed for other causes of liver injury and discontinue ozanimod if not other cause is found. There is no known cross sensitivity of the hepatic injury from ozanimod with other agents used to treat multiple sclerosis. Because of the similarity in chemical structure and mechanism of action, there may be cross sensitivity to side effects with fingolimod, siponimod, and ponesimod.

Drug Class: Multiple Sclerosis Agents

Other Drugs in the Subclass, S1P Receptor Modulators: Fingolimod, Ponesimod, Siponimod

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ozanimod – Zeposia®

DRUG CLASS

Multiple Sclerosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ozanimod)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Ozanimod | 1306760-87-1 | C23-H24-N4-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 25 November 2025

Abbreviations: HBV, hepatitis B virus; MRI, magnetic resonance imaging; S1P, sphingosine-1-phosphate.

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 697-8. (Expert review of hepatotoxicity published in 1999 before the availability of S1P receptor modulators).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Multi-authored textbook of hepatotoxicity published in 2013, does not discuss the drugs for multiple sclerosis).
Krensky AM, Azzi JR, Hafler DA. Immunotherapy for multiple sclerosis. Immunosuppressants and Tolerogens. In, Brunton LL, Halal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 649-52. (Textbook of pharmacology and therapeutics).
FDA Medical Review of NDA for Ozanimod: Pages 92-99. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/209899Orig1s000MedR.pdf (FDA website with product labels and medical review of the efficacy and safety of ozanimod mentions that serum aminotransferase elevations above 5 times ULN arose in 10 of 1944 [1%] patients treated with ozanimod and led to dose interruption/discontinuation in ~1%, but careful analysis of specific cases did not find any instance of clinically apparent acute liver injury with jaundice).
Kappos L, Radue EW, O'Connor P, Polman C, Hohlfeld R, Calabresi P, Selmaj K, et al.; FREEDOMS Study Group. A placebo-controlled trial of oral fingolimod in relapsing multiple sclerosis. N Engl J Med 2010; 362: 387-401. (Among 1272 patients with relapsing multiple sclerosis treated with fingolimod [0.5 or 1.25 mg daily] or placebo for 24 months, 8.5-12.5% of fingolimod, but only 1.7% of placebo recipients developed ALT elevations above 3 times ULN, and ALT levels fell to normal with or without discontinuation, and serum bilirubin levels did not change). 20089952
Oral fingolimod (gilenya) for multiple sclerosis. Med Lett Drugs Ther 2010; 52 (1353-1354): 98-9. (Concise review of mechanism of action, efficacy, safety and costs of fingolimod shortly after is approval for use for multiple sclerosis in the US, mentions that common side effects are headache, cough, diarrhea, back pain and aminotransferase elevations; no mention of clinically apparent liver injury). 21344782
Subei AM, Cohen JA. Sphingosine 1-phosphate receptor modulators in multiple sclerosis. CNS Drugs 2015; 29: 565-75. (Review of the function of the S1P receptors [subtypes 1 to 5] and the clinical implications of their differential modulation by different inhibitors). 26239599
Cohen JA, Arnold DL, Comi G, Bar-Or A, Gujrathi S, Hartung JP, Cravets M, et al.; RADIANCE Study Group. Safety and efficacy of the selective sphingosine 1-phosphate receptor modulator ozanimod in relapsing multiple sclerosis (RADIANCE): a randomised, placebo-controlled, phase 2 trial. Lancet Neurol 2016; 15: 373-81. (Among 258 adults with relapsing multiple sclerosis treated with ozanimod [0.5 or 1.0 mg] or placebo once daily for 24 weeks, the accumulative number of brain MRI enhancing lesions were less with ozanimod [1.5] than placebo [11] and adverse event rates were similar [61% vs 59%], ALT elevations above 3 times the ULN arose in 1.5% vs none on placebo, but no patient required drug discontinuation because of an adverse event). 26879276
Sandborn WJ, Feagan BG, Wolf DC, D'Haens G, Vermeire S, Hanauer SB, Ghosh S, et al.; TOUCHSTONE Study Group. Ozanimod induction and maintenance treatment for ulcerative colitis. N Engl J Med 2016; 374: 1754-62. (Among 197 adults with ulcerative colitis treated with ozanimod [0.5 or 1.0 mg] vs placebo once daily for up to 32 weeks, clinical remissions by 8 weeks occurred in 14% and 16% on ozanimod vs 6% on placebo, while adverse event rates were similar in all groups, ALT elevations above 3 times ULN arose in 3% on ozanimod vs none on placebo, but there were no severe hepatic adverse events). 27144850
Filippi M, Bar-Or A, Piehl F, Preziosa P, Solari A, Vukusic S, Rocca MA. Multiple sclerosis. Nat Rev Dis Primers 2018; 4: 43. (Review of the pathogenesis, clinical features, natural history, management and therapy of multiple sclerosis). 30410033
Siponimod (Mayzent)--a new drug for multiple sclerosis. Med Lett Drugs Ther 2019; 61(1571): 70-2. (Concise review of the mechanism of action, clinical efficacy, safety and costs of siponimod in comparison to other agents used to treat multiple sclerosis; mentions that serum aminotransferase elevations can occur with siponimod therapy and that patients should be tested for liver function tests and have CYP 2C9 genotype testing before starting treatment). 31169805
Al-Salama ZT. Siponimod: first global approval. Drugs 2019; 79: 1009-15. (Review of the mechanism of action, history of development, clinical efficacy and safety of siponimod; mentions the common side effects include headache, hypertension, aminotransferase elevations, peripheral edema, nausea, dizziness, diarrhea, bradycardia and musculoskeletal pain, but that the aminotransferase levels were rarely severely elevated). 31144287
Cohen JA, Comi G, Arnold DL, Bar-Or A, Selmaj KW, Steinman L, Havrdová EK, et al.; RADIANCE Trial Investigators. Efficacy and safety of ozanimod in multiple sclerosis: Dose-blinded extension of a randomized phase II study. Mult Scler 2019; 25: 1255-62. (In a two year extension study of ozanimod [0.5 or 1.0 mg once daily] in 247 adults with relapsing multiple sclerosis [Cohen 2016], 5% of patients developed ALT or AST elevations above 3 times ULN and 4 subjects [1.6%] required drug discontinuation for ALT elevations above 5 times ULN, but all resolved rapidly and none developed symptoms or jaundice). 30043658
Comi G, Kappos L, Selmaj KW, Bar-Or A, Arnold DL, Steinman L, Hartung HP, et al.; SUNBEAM Study Investigators. Safety and efficacy of ozanimod versus interferon beta-1a in relapsing multiple sclerosis (SUNBEAM): a multicentre, randomised, minimum 12-month, phase 3 trial. Lancet Neurol 2019; 18: 1009-20. (Among 1346 adults with relapsing multiple sclerosis treated with ozanimod [0.5 or 1.0 mg orally once daily] or interferon beta [30 µg intramuscularly once weekly] for at least 12 months, the annual relapse rate was less with ozanimod [0.18 and 0.24] than interferon beta [0.35], and while adverse event rates were less with ozanimod, ALT elevations above 3 times ULN arose in 3.0% vs 2.2% and discontinuations for ALT elevations in 0.6% vs 0.2%, but there were no cases of clinically apparent liver injury with jaundice). 31492651
Cohen JA, Comi G, Selmaj KW, Bar-Or A, Arnold DL, Steinman L, Hartung HP, et al.; RADIANCE Trial Investigators. Safety and efficacy of ozanimod versus interferon beta-1a in relapsing multiple sclerosis (RADIANCE): a multicentre, randomised, 24-month, phase 3 trial. Lancet Neurol 2019; 18: 1021-33. (Among 1313 adults with relapsing multiple sclerosis treat with oral ozanimod [0.5 or 1.0 mg daily] or intramuscular interferon beta 1a [30 µg weekly], annualized relapse rates over 2 years were lower with ozanimod [0.22 and 0.17 vs 0.28], as were adverse event rates [74% and 75% vs 83%] while rates of ALT elevations above 3 times ULN were slightly higher [6.7% and 5.9% vs 3.9%])., although there were no instances of clinically apparent liver injury with jaundice). 31492652
Lamb YN. Ozanimod: first approval. Drugs 2020; 80: 841-8. (Review of the mechanism of action, pharmacology, clinical efficacy and safety of ozanimod shortly after its approval for use in multiple sclerosis in the US mentions that ALT and AST elevations arose in 10% of patients treated in large controlled trials in comparison to 5% in patients receiving interferon beta-1a; no mention of clinically apparent hepatotoxicity). 32385738
Feagan BG, Sandborn WJ, Danese S, Wolf DC, Liu WJ, Hua SY, Minton N, et al. Ozanimod induction therapy for patients with moderate to severe Crohn's disease: a single-arm, phase 2, prospective observer-blinded endpoint study. Lancet Gastroenterol Hepatol 2020; 5: 819-28. (Among 69 patients with active Crohn disease treated with ozanimod [1 mg daily] for 12 weeks, improvements occurred in clinical, endoscopic and histologic features, and adverse events were largely due to the underlying disease; 7% of patients had ALT elevations, 4% rising to above 3 times the ULN, but none were associated with jaundice or required drug discontinuation). 32553149
Ozanimod (Zeposia) for multiple sclerosis. Med Lett Drugs Ther 2020; 62(1605): 132-4. (Concise review of the mechanism of action, clinical efficacy, toxicity and costs of ozanimod shortly after its approval for use in relapsing multiple sclerosis in the US mentions that ozanimod is associated with ALT and AST elevations and that therapy lowers lymphocyte counts and increases the risk of infections including herpes zoster). 32970043
Lu MC, Shih YL, Hsieh TY, Lin JC. Flare of hepatitis B virus after fingolimod treatment for relapsing and remitting multiple sclerosis. J Formos Med Assoc 2020; 119: 886-7. (Letter describing 41 year old Taiwanese woman with relapsing multiple sclerosis and inactive HBsAg carrier state who developed reactivation of hepatitis B after 35 months of treatment with fingolimod [ALT 385 U/L, HBV DNA 8 log_10_ IU/mL, bilirubin not given] who responded to tenofovir, with resolution of ALT elevations and decrease of HBV DNA levels to undetectable despite continuation of fingolimod). 31679907
Drugs for multiple sclerosis. Med Lett Drugs Ther 2021; 63(1620): 42-8. (Concise review of the relative clinical efficacy, safety and costs of drugs for relapsing multiple sclerosis including parenteral agents [such as interferon-beta, glatiramer acetate, natalizumab, alemtuzumab, ocreliumab, ofatumumab, rituximab and mitoxantrone] and the oral agents [such as the S1P receptor modulators, cladribine, fumarates, and teriflunomide], many of which are associated with serum ALT elevations and several have been reported to cause clinically apparent liver injury or reactivation of hepatitis B). 33976089
Selmaj KW, Cohen JA, Comi G, Bar-Or A, Arnold DL, Steinman L, Hartung HP, et al. Ozanimod in relapsing multiple sclerosis: pooled safety results from the clinical development program. Mult Scler Relat Disord 2021; 51: 102844. (Analysis of treatment emergent adverse events from pooled results of 5 preregistration trials in 2631 patients who received ozanimod for a mean of 32 months, identified no serious opportunistic infections, 37 cases of herpes zoster and 40 of oral herpes; elevations in ALT arose in 5% which were above 3 times the ULN in 3.9%, but with no clear temporal pattern and with no case of severe drug induced liver injury). 33892317
Sandborn WJ, Feagan BG, Hanauer S, Vermeire S, Ghosh S, Liu WJ, Petersen A, et al. Long-term efficacy and safety of ozanimod in moderately to severely active ulcerative colitis: results from the open-label extension of the randomized, phase 2 TOUCHSTONE Study. J Crohns Colitis 2021; 15: 1120-9. (Among 170 patients with ulcerative colitis who participated in a placebo controlled trial and were then enrolled in an open-label extension study of ozanimod [1 mg daily], clinical improvements were frequent and usually sustained; ALT elevations arose in 3.5% of subjects, but “no clinically significant elevations in hepatic transaminases and no evidence of serious hepatocellular injury were observed”). 33438008
McGinley MP, Cohen JA. Sphingosine 1-phosphate receptor modulators in multiple sclerosis and other conditions. Lancet 2021;398:1184-94.. (Review of the function of S1P receptors and the mechanism of action of S1P receptor modulators in affecting lymphocyte tracking out of lymph nodes into the circulation and tissues; fingolimod is a nonspecific modulator affecting all 5 forms of S1P receptors, whereas siponimod and ozanimod act predominantly on S1P receptors 1 and 5 and ponesimod against S1P receptor-1 alone, the activity against S1P receptor-1 accounting for most of the beneficial effects in multiple sclerosis and the restricted specificity perhaps accounting for the lower rate of cardiac, lung and eye adverse events driven mostly by the inhibition of the other S1P receptor subtypes). 34175020
Cree BA, Selmaj KW, Steinman L, Comi G, Bar-Or A, Arnold DL, Hartung HP, et al. Long-term safety and efficacy of ozanimod in relapsing multiple sclerosis: up to 5 years of follow-up in the DAYBREAK open-label extension trial. Mult Scler. 2022;28:1944-1962.. (Among 2494 patients with relapsing multiple sclerosis treated with ozanimod for up to 5 years, 86% had an adverse event that was severe in 7.6%, ALT elevations above 3 times ULN arose in 3.2% and above 5 times ULN in 0.7%, leading to discontinuations in 0.4% , but there were no instances of severe drug-induced liver injury [as marked by ALT elevations with jaundice]). 35765217
Signoriello E, Romano G, Foschi M, Zanghì A, D'Amico E, Fantozzi R, Centonze D, et al. Switch from fingolimod to ozanimod for safety or intolerance reasons. Ther Adv Neurol Disord. 2025;18:17562864251328191.. (Among 60 patients with relapsing multiple sclerosis who were switched from fingolimod to ozanimod because of adverse events, 58 [97%] tolerated ozanimod, and mean serum ALT levels decreased from 90 U/L to 53 U/L, and rate of ALT elevations from 22% to 9%). 40655996
Tang Q, Tang X, Hu X, Yin W, Luo L, Li Y, Zhong X. A real-world data analysis of ozanimod in the FDA Adverse Event Reporting System (FAERS) database. Medicine (Baltimore). 2025;104(37): e44535.. (Among 5469 spontaneous adverse event reports attributed to ozanimod made to the FDAs Adverse Event Reporting System [FAERS] during 2020 to 2023, 50 [1%] were hepatic enzyme elevations; no details provided). 40958239
Selmaj KW, Steinman L, Comi G, Bar-Or A, Arnold DL, Hartung HP, Montalbán X, et al. Long-term safety and efficacy of ozanimod in relapsing multiple sclerosis: final analysis of the DAYBREAK open-label extension trial. Mult Scler. 2025;31:1557-1571.. (Among the 2454 patients with relapsing multiple sclerosis enrolled in an open-label, long term trial of ozanimod, adverse events arose in 89%, which were serious in 15% and led to discontinuation in 3.9%; the rate of any ALT elevation was 41%, greater than 3 times ULN 3.7%, greater than 5 times 0.8%, and greater than 10 times 0.4%, but none were accompanied by jaundice so that there were no instances of clinically apparent drug-induced liver injury). 41190505
Woodson S, Gettings EJ, Guo CY, Klineova S, Lee JM, Romero RS, Walker A, et al. Comparative effectiveness of fumarates versus sphingosine-1-phosphate receptor modulators in Black patients with multiple sclerosis. Neurol Ther. 2025;14:1627-1639.. (Analysis of health claim reports identified 1664 Black patients with multiple sclerosis who were treated a fumarate [n=2131] or an S1P receptor modulator [n=433] between 2017 and 2023, the annualized relapse rates were 0.34 vs 0.35 and 75% of patients remained relapse free; no mention of adverse event rates). 40522622
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, one case was attributed to fingolimod and one to natalizumab, but no other agents used to treat multiple sclerosis were listed: personal communication). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Ozanimod: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Ozanimod/AE)%20AND%20Human%5bMH%5d%20AND%20(drug%20induced%20liver%20injury%20OR%20jaundice/CI%20OR%20bile%20duct%20diseases/CI%20OR%20liver/DE%20OR%20liver%20diseases/CI)%20AND%20(%221900%5C%5C1%5C%5C1%22%5bEDat%5d:%222999%5C%5C12%5C%5C31%22%5bEDat%5d))

2. Trials on Ozanimod: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ozanimod)